# Sevoflurane

## OVERVIEW

### Introduction

Sevofurane is one of the most commonly used volatile anesthetic agents, particularly for outpatient anesthesia and has an excellent safety record. Sevoflurane has been implicated in rare single case reports of severe acute liver injury similar to halothane hepatitis.

### Background

Sevoflurane (see' voe flur' ane) is a widely used major anesthetic agent with rapid onset of action and rapid dispersal. Because of its rapid onset of action and lack of irritability to the airways, sevoflurane can be used to both induce and maintain anesthesia. Sevoflurane became available for use in the United States in 1995. Sevoflurane must be administered in a controlled situation by a properly trained and credentialed anesthesiologist or nurse anesthetist and is typically given in concentrations of 2% to 4% with oxygen.

### Hepatotoxicity

Prospective, serial blood testing often demonstrates minor transient elevations in serum aminotransferase levels in the 1 to 2 weeks after major surgery. Appearance of ALT levels above 10 times the upper limit of normal, however, is distinctly unusual and points to significant hepatotoxicity. Clinically apparent, severe hepatic injury from sevoflurane is very rare, only isolated case reports having been published. The injury is marked by acute elevations in serum aminotransferase levels (5- to 50-fold) and appearance of jaundice within 2 to 21 days of surgery. There are usually minimal increases in alkaline phosphatase and gammaglutamyl transpeptidase levels. Jaundice is usually preceded by a day or two of fever and may be accompanied by rash and eosinophilia. The acute liver injury may be self-limited and resolve within 4 to 8 weeks, but can be severe and associated with acute liver failure. A strong risk factor is previous exposure to any of the halogenated anesthetics and particularly a history of halothane hepatitis or unexplained fever and rash after anesthesia with one of these agents. The differential diagnosis of acute liver injury after surgery and anesthesia is sometimes difficult, and a clinical picture similar to sevoflurane induced hepatitis can be caused by shock or ischemia, sepsis, other idiosyncratic forms of drug induced liver injury and acute viral or herpes hepatitis.

Likelihood score: B (highly likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of sevoflurane hepatotoxicity is suspected to be similar to that of halothane and associated with creation of reactive intermediates. Sevoflurane is metabolized to a small extent by the microsomal drug metabolizing enzyme CYP 2E1 to a trifluoroacetylated reactive intermediate (TFA) that is capable of binding to multiple intracytoplasmic proteins forming potentially immunogenic adducts. The TFA adducts induce antibodies that can be detected in patients with sevoflurane- as well as halothane hepatotoxicity and are also found in a proportion of health care workers exposed to the volatile anesthetics.

### Outcome and Management

Severity ranges from mild and transient aminotransferase elevations without symptoms or other evidence of liver injury, to a self limited symptomatic acute hepatitis-like reaction to a severe, acute hepatic failure. The severity and prognosis may relate in part of patient age, being more severe in the elderly and both milder and less common in children. Obesity may also be both a predisposing factor and predictor of outcome. Chronic liver injury from sevoflurane exposure has not been described. Patients with sevoflurane induced hepatitis should be cautioned against future exposure to a fluorinated hydrocarbon anesthetic such as halothane, enflurane, isoflurane or desflurane.

Drug Class: Halogenated Anesthetics

Other Drugs in the Class: Desflurane, Enflurane, Halothane, Isoflurane

## CASE REPORTS

### Case 1. Suspected sevoflurane induced acute liver injury.

[Modified from a case in the database of the Drug-Induced Liver Injury Network]

A 49 year woman underwent arthroscopic surgery on her knee using midazolam, fentanyl, propofol and sevoflurane. She received a single IV infusion of cefazolin at the time of surgery. Eighteen days after surgery, she developed nausea, heartburn, and pruritus followed by dark urine. She had undergone general anesthesia three times in the past, but not in the previous year and the anesthetics used were not known. On admission, she was afebrile and physical examination revealed jaundice and mild hepatic tenderness. Laboratory tests showed elevations in serum enzymes and a total bilirubin of 4.0 mg/dL. There was no eosinophilia. Tests for hepatitis A, B and C and autoantibodies were normal. A liver ultrasound showed a gall bladder polyp, but no evidence of biliary obstruction. A liver biopsy showed cholestatic hepatitis with mild bile duct injury. She recovered rapidly and was asymptomatic and had normal liver tests a few weeks later.

#### Key Points

Medication: | Sevoflurane, 60 minutes anesthesia time
Pattern: | Hepatocellular (R=5.4)
Severity: | 3+ (hospitalization for jaundice)
Latency: | 18 days to symptoms
Recovery: | 3 weeks
Other medications: | Anesthesia included fentanyl, propofol and versed. One dose of cefazolin given at the time of surgery. Postoperatively given ibuprofen, naproxen, hydrocodone, and occasional acetaminophen. Chronic therapy of allergies with Allegra and Nasonex.

#### Laboratory Values

Postoperative Days | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | Arthroscopic surgery under sevoflurane anesthesia
24 | 618 | 328 | 4.0
25 | 630 | 373 | 5.1 | Liver biopsy
28 | 543 | 406 | 5.0
34 | 267 | 285 | 1.3
39 | 119 | 181 | 0.7
Normal Values | <45 | <130

#### Comment

This patient developed jaundice and hepatic injury within 3 weeks of surgery under sevoflurane anesthesia. While the liver injury was attributed to the anesthetic by the reviewing physicians, the pattern of onset (latency of 3 weeks), clinical features (absence of fever, early appearance of pruritus) and liver histology (cholestasis) were atypical of anesthetic induced hepatotoxicity and more characteristic of penicillin or cephalosporin induced liver disease. The liver biopsy suggested a cholestatic hepatitis, even though the initial liver enzyme elevations were “hepatocellular”. Indeed, this case was later re-adjudicated as being very likely due to cefazolin rather than sevoflurane.

### Case 2. Sevoflurane induced acute liver injury.

[Modified from: Singhal S, Gray T, Guzman G, Verma A, Anand K. Sevoflurane hepatotoxicity: a case report of sevoflurane hepatic necrosis and review of the literature. Am J Ther 2010; 17: 219-22. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/19455019)]

A 37 year man underwent resection of an abdominal wall mass under midazolam, nitrous oxide, propofol and sevoflurane anesthesia and was discharged the same day. Three days after surgery, he developed nausea, vomiting, abdominal pain and jaundice. He had no history of liver disease, drug reactions, alcohol abuse or risk factors for viral hepatitis. He had undergone an appendectomy under general anesthesia four years previously, but the anesthetics used were not known. Other medications included postoperative pain management with codeine and acetaminophen (<1 gram daily). On admission, laboratory tests showed mild jaundice (total bilirubin 4.2 mg/dL, direct 1.8 mg/dL), but marked elevations in serum aminotransferase levels (ALT 3364 U/L, AST 3013 U/L) and minimal increase in alkaline phosphatase (336 U/L) and mild eosinophilia. These values had been mildly elevated one week previously at the time of a preoperative evaluation (Table). Tests for hepatitis A and B and autoantibodies were normal. Tests for Ebstein Barr virus suggested recent infection. A liver ultrasound showed no gallstones or evidence of biliary obstruction. During the first few days after admission he worsened with deepening jaundice and coagulopathy, the INR rising to 4.8. A liver biopsy showed centrolobular necrosis and inflammation and cholestasis with minimal or no fibrosis, suggestive of acute drug induced liver injury. Liver transplantation was considered, but he then began to improve spontaneously and over the next 4 months his symptoms resolved and liver test results returned to normal.

#### Key Points

Medication: | Sevoflurane anesthesia
Pattern: | Hepatocellular (R=20)
Severity: | 4+ (hospitalization, jaundice and coagulopathy)
Latency: | 3 days to symptoms
Recovery: | 4 months
Other medications: | Anesthesia included nitrous oxide, propofol and midazolam. Postoperatively given acetaminophen (<1 gram daily) and codeine for pain

#### Laboratory Values

Postoperative Days | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | 199 | 188 | 0.8
3 | 3064 | 336 | 4.2 | Admission
6 | 4861 | 308 | 9.3
8 | 4137 | 292 | 12.7
10 | 1456 | 212 | 16.5
13 | 619 | 200 | 25.6 | Liver biopsy
18 | 130 | 208 | 30.4
21 | 120 | 214 | 31.2
60 | 43 | 364 | 16.1
105 | 39 | 140 | 1.3
Normal Values | <60 | <121 | <1.2

#### Comment

This patient developed jaundice and severe hepatic injury within 3 days of surgery under sevoflurane anesthesia. The clinical course was typical of halogenated anesthetic liver injury with a rapid onset, mild eosinophilia, a hepatocellular pattern of injury and severe course. Risk factors included previous anesthesia (although the agent used was not known). Unexplained were the abnormal liver tests obtained before surgery and the equivocal serology of EBV infection. Results of tests for hepatitis C and E were not provided.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sevoflurane – Generic, Sevorane®, Ultane®

DRUG CLASS

Anesthetics, Halogenated

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=halogenated+anesthetics)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Sevoflurane | 28523-86-6 | C4-H3-F7-O | Sevoflurane chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 01 January 2018

Zimmerman HJ. Anesthetic agents. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 457-82. (Expert review of hepatotoxicity of anesthetic agents published in 1999; mentions that the newer halogenated anesthetics appear to be safer than halothane, but that hints of liver injury from desflurane and sevoflurane have appeared).
Kenna JG. Mechanism, pathology, and clinical presentation of hepatoxicity of anesthetic agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 403-22. (Review of liver injury from anesthetic agents mentions that several cases of sevoflurane hepatotoxicity were reported from Japan, where it was used widely at least 10 years before introduction into the United States, and several cases have subsequently been reported from other countries).
Patel PM, Patel HH, Roth DM. General anesthetics and therapeutic gases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 527-64. (Textbook of pharmacology and therapeutics).
Ogawa M, Doi K, Mitsufuji T, Satoh K, Takatori T. [Drug induced hepatitis following sevoflurane anesthesia in a child] Masui 1991; 40: 1542-5. Japanese. (11 year old boy with first exposure to sevoflurane developed 15-20 fold elevations in ALT and AST without jaundice 11-22 days after anesthesia). 1766104
Shichinohe Y, Masuda Y, Takahashi H, Kotaki M, Omote T, Shichinohe M, Namiki A. [A case of postoperative hepatic injury after sevoflurane anesthesia] Masui 1992; 41: 1802-5. Japanese. (63 year old man underwent surgery under sevoflurane anesthesia and had ALT elevations starting on postoperative day 3 and jaundice on day 7 [peak bilirubin 14.5 mg/dL, ALT 700 U/L], resolving within 2 months). 1460759
Watanabe K, Hatakenaka S, Ikemune K, Chigyo Y, Kubozono T, Arai T. [A case of suspected liver dysfunction induced by sevoflurane anesthesia] Masui 1993; 42: 902-5. Japanese. (One month old male infant developed fever followed by 5-8 fold elevations in ALT [326 KU/L], AST [242 KU/L] and LDH [901 WU/L], without jaundice after sevoflurane anesthesia). 8320810
Ohmori H, Seki S, Kanaya N, et al. A case report of postoperative liver dysfunction following sevoflurane anesthesia after isoflurane anesthesia. J Jpn Soc Clin Anesth 1994; 14: 68-71. Not in PubMed.
Fee JP, Thompson GH. Comparative tolerability profiles of the inhaled anaesthetics. Drug Saf 1997; 16: 157-70. (Review of metabolism and literature on hepatotoxicity of halogenatic anesthetics: halothane is extensively metabolized [oxidized] by the liver and major metabolite is TFA which may be a toxic intermediary metabolite). 9098654
Nishiyama T, Yokoyama T, Hanaoka K. Liver function after sevoflurane or isoflurane anaesthesia in neurosurgical patients. Can J Anaesth 1998; 45: 753-6. (Prospective analysis of ALT, AST, Alk P and bilirubin levels after sevoflurane or isoflurane [n=45 each] showed minimal increases in ALT and AST peaking at 7 days; elevated in ~20% of patients, but none were symptomatic or jaundiced). 9793665
Bruun LS, Elkjaer S, Bitsch-Larsen D, Andersen O. Hepatic failure in a child after acetaminophen and sevoflurane exposure. Anesth Analg 2001; 92: 1446-8. (3 year old girl developed marked ALT [>10,000 U/L], AST [>7000 U/L] and LDH [37,923 U/L] elevations by day 4 after appendectomy under sevoflurane anesthesia, with jaundice [3.5 mg/dL], coma and coagulopathy, ultimately resolving; exposed to many other drugs including rectal acetaminophen). 11375824
Siddiqui MS, Vollers JM, Mayhew JF. Did sevoflurane contribute to hepatic failure in a child given large doses of acetaminophen? Anesth Analg 2002; 95: 253; (Letter arguing that case described by Bruun [2001] was due to acetaminophen). 12088983
Reich A, Everding AS, Bulla M, Brinkmann OA, Van Aken H. Hepatitis after sevoflurane exposure in an infant suffering from primary hyperoxaluria type 1. Anesth Analg 2004; 99: 370-2, table of contents. (11 month of infant developed marked ALT [543 U/L], AST [683 U/L] and LDH [960 U/L] elevations 2 days after sevoflurane anesthesia, which returned to baseline within days without jaundice, fever, or eosinophilia, possibly due to ischemic hepatitis). 15271707
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, of which 3 were attributed to halothane and 1 to isoflurane, but none to other halogenated anesthetics). 15390328
Jang Y, Kim I. Severe hepatotoxicity after sevoflurane anesthesia in a child with mild renal dysfunction. Paediatr Anaesth 2005; 15: 1140-4. (6 year old girl had rise of ALT [peak 744 U/L] and AST [peak 2125 U/L] levels 2-7 days after renal biopsy and sevoflurane anesthesia, with fever and malaise but no jaundice; no previous exposures). 16324041
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (36 years of reporting to Swedish registry identified 103 cases of acute liver failure due to drugs, of which 16 were attributed to halothane [ranking #1], but none to other halogenated anesthetics). 16165719
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (In WHO database of fatal adverse drug reactions from 1968-2003, there were 4690 reports of drug induced liver fatalities; halothane ranked fifth in frequency but most cases were reported before 1991). 16054882
Lehmann A, Neher M, Kiessling AH, Isgro F, Koloska A, Boldt J. Case report: fatal hepatic failure after aortic valve replacement and sevoflurane exposure. Can J Anaesth 2007; 54: 917-21. (76 year old woman developed acute liver failure within days of sevoflurane anesthesia for cardiac surgery [bilirubin 1.0 rising to 2.7 mg/dL, ALT 10504 U/L, Alk P 125 U/L, LDH 12,944 U/L]; course more typical of ischemic than anesthetic hepatitis). 17975238
Turillazzi E, D'Errico S, Neri M, Riezzo I, Fineschi V. A fatal case of fulminant hepatic necrosis following sevoflurane anesthesia. Toxicol Pathol 2007; 35: 840-5. (69 year old man developed marked rises in ALT [641 U/L], AST [2196 U/L] and LDH 20 hours after initial surgery under sevoflurane anesthesia, with further rises >1000 U/L after emergency surgery and reexposure to sevoflurane, with death 8 days later). 17943651
Alotaibi WM. Severe hepatic dysfunction after sevoflurane exposure. Saudi Med J 2008; 29: 1344-6. (6 year old underwent craniotomy under sevoflurane anesthesia developed high ALT levels [2891 U/L] immediately postoperatively, which fell to normal by day 7 at which time she developed thrombocytopenia, intracerebral bleeding and coma resulting in death by day 9). 18813426
Fernández-Meré LA, Muñoz González F, Sopena Zubiria LA, Alvarez Blanco M. [Sevoflurane and liver dysfunction]. Rev Esp Anestesiol Reanim 2008; 55 :184-5. Spanish. (61 year old woman developed fatigue, fever and elevations in ALT [334 and 109 U/L and GGT 121 and 194 U/L] 2 to 4 weeks after sevoflurane anesthesia on two occasions without jaundice and with full resolution in 2 weeks). 18401994
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease collected in the US between 2003 and 2008, 2 cases were attributed to desflurane and 1 to sevoflurane [see Case 1], none to other halogenated anesthetics). 18955056
Zizek D, Ribnikar M, Zizek B, Ferlan-Marolt V. Fatal subacute liver failure after repeated administration of sevoflurane anaesthesia. Eur J Gastroenterol Hepatol 2010; 22: 112-5. ( 66 year old woman exposed to sevoflurane anesthesia twice in 25 days developed jaundice and subacute liver failure arising 2 weeks later [bilirubin 31.5 mg/dL, ALT 2400 U/L, Alk P 282 U/L, INR 2.0], progressing to hepatic failure and death 66 days after second anesthesia; autopsy showed massive necrosis). 19657276
Singhal S, Gray T, Guzman G, Verma A, Anand K. Sevoflurane hepatotoxicity: a case report of sevoflurane hepatic necrosis and review of the literature. Am J Ther 2010; 17: 219-22. (37 year old man developed nausea and jaundice 3 days after sevoflurane anesthesia [bilirubin 4.2 rising to 30.4 mg/dL; ALT 3364 U/L, Alk P 336 U/L], resolving within 3 months). 19455019
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/20648003) (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; none were attributed to anesthetic agents).
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. Multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury inlcuding one due to halothane and one to isoflurane, but none to other anesthetic agents). 20949552
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/21039766) (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, no anesthetic agent ranked in the top 41 causes).
Nicoll A, Moore D, Njoku D, Hockey B. Repeated exposure to modern volatile anaesthetics may cause chronic hepatitis as well as acute liver injury. BMJ Case Rep 2012; 2012. (Description of 4 cases of chronic hepatitis in patients who had repeated surgical exposures to sevoflurane and were found to have antibodies to CYP 2E1 and TFA).23131606
Masin-Spasovska J, Dimitrovski K, Stavridis S, Stankov O, Dohcev S, Saidi S, Jakovski K, et al. Acute fulminant hepatatis in kidney transplant recipient after repeated sevoflurane anesthesia--a case report and literature review. Curr Drug Saf 2013; 8: 141-4. (47 year old woman developed renal failure and hypotension after renal transplantation and required reoperation 2 days later, which was followed by ALT [3,300 U/L] and LDH [8,900 U/L] elevations which the authors attributed to sevoflurane anesthesia, but may have been due to shock and ischemia). 23845191
Nishiyama T. Effects of repeat exposure to inhalation anesthetics on liver and renal function. J Anaesthesiol Clin Pharmacol 2013; 29: 83-7. (Retrospective analysis of 206 patients who underwent anaesthesia twice within a 1 year period found higher rates of ALT elevations within 16 days after isoflurane [60-83%] than sevoflurane [24-30%] or propofol-fentanyl [12-17%], most elevations being less than twice ULN and no differences between first and second exposures). 23493664
Safari S, Motavaf M, Seyed Siamdoust SA, Alavian SM. Hepatotoxicity of halogenated inhalational anesthetics. Iran Red Crescent Med J 2014; 16: e20153. (Review of hepatotoxicity of the volatile halogenated anesthetics). 25593732
Lin J, Moore D, Hockey B, Di Lernia R, Gorelik A, Liew D, Nicoll A. Drug-induced hepatotoxicity: incidence of abnormal liver function tests consistent with volatile anaesthetic hepatitis in trauma patients. Liver Int 2014; 34: 576-82. (Retrospective analysis of records from 1556 patients admitted to a trauma unit during 2008 identified 47 cases of possible volatile anesthetic related liver injury, including 12 who developed ALT levels above 200 U/L of whom 11 had fever and 6 eosinophilia, but none were jaundiced or developed acute liver failure). 23944929
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases of which 5 [3%] were attributed to halothane and caused acute liver failure, while no other volatile anesthetic was listed). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 2 were attributed to isoflurane, 1 to sevoflurane, but none to halothane, enflurane or desflurane). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Sevoflurane: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=sevoflurane+AND+methyl+ethers/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222009/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Sevoflurane: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=sevoflurane)